# Carglumic Acid

## OVERVIEW

### Introduction

Carglumic acid is an orphan drug and a derivative of N-acetylglutamate that activates the first enzyme in the urea cycle that is responsible for removal and detoxification of ammonia, making this drug a valuable agent for therapy of hyperammonemia caused by rare forms of urea cycle defects. Clinical experience with carglumic acid is limited, but it has not been linked to significant serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Carglumic (kar gloo' mik) acid is a small molecule that resembles N-acetylglutamate, a normal occurring metabolite that activates the enzyme carbamoyl phosphate synthetase I (CPS-1), the first step in the urea cycle which is responsible for removal and detoxification of ammonia. Carglumic acid is used to treat the severe hyperammonemia that occurs in the urea cycle disorder caused by deficiency of hepatic N-acetylglutamate synthase (NAGS) which normally produces N-acetylglutamate. Carglumic acid was shown to decrease ammonia levels during acute exacerbation of NAGS deficiency as well as decreasing levels chronically between acute episodes. Carglumic acid was approved as oral therapy of NAGS deficiency in the United States in 2010. It has been used experimentally and off-label to treat other genetic as well as acquired causes of severe hyperammonemia including idiopathic cases due to valproate and cancer chemotherapy and secondary genetic cases due to organic acidurias such as isovaleric, methylmalonic and propionic aciduria. Carglumic acid is available in tablets of 200 mg under the brand name Carbaglu. The initial dose for acute hyperammonemia is 100 to 250 mg/kg daily given in 2 to 4 divided doses. The typical dose for maintenance therapy is 100 mg/kg daily. The tablets are not swallowed whole, but rather dispersed in small amounts of water just before oral administration. Side effects are generally dose related and can include nausea, vomiting, abdominal pain, diarrhea, and fever.

### Hepatotoxicity

The urea cycle disorders include at least 8 genetic conditions, one of the more rare causes being NAGS. Because this condition is so rare, carglumic acid was given orphan disease drug status and approval was based on open labelled treatment studies of only 40 patients. In these studies, carglumic acid was not linked to serum enzyme elevations during treatment or to episodes of acute, clinically apparent liver injury or jaundice. Since approval, there have been no published reports of hepatotoxicity attributed to carglumic acid and the product label does not mention liver injury as an adverse event.

Likelihood score: E (unlikely cause of clinically apparent liver injury, but experience with its use is limited).

### Mechanism of Injury

The mechanism by which carglumic acid might cause serum aminotransferase elevations or liver injury is not known. It is a modified form of glutamic acid that is produced naturally in hepatocytes and is likely metabolized by many cells.

Drug Class: Genetic Disorder Agents, Urea Cycle Disorder Agents (Hyperammonemia)

Other drugs in the Subclass: Lactulose, Phenylbutyrate, Rifaximin, Sodium Benzoate

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carglumic Acid – Carbaglu®

DRUG CLASS

Urea Cycle Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Carglumic%20Acid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Carglumic Acid | 1188-38-1 | C6-H10-N2-O5 | Carglumic Acid structure
N-acetylglutamate | 1188-37-1 (https://chem.sis.nlm.nih.gov/chemidplus/direct.jsp?regno=1188-37-1) | C7-H11-N-O5 | N-acetylglutamate structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 October 2016

Abbreviation used for urea cycle enzyme deficiencies: N-acetylglutamate synthase (NAGS).

Bachmann C, Krähenbühl S, Colombo JP, Schubiger G, Jaggi KH, Tönz O. N-acetylglutamate synthetase deficiency: a disorder of ammonia detoxication. N Engl J Med 1981; 304: 543. ( Initial description of a newborn with hyperammonemia that could not be attributed to a known urea cycle defect, but was associated with lack of N-acetylglutamate synthase (NAGS), N-acetylglutamate being the activator of cabamylphosphate synthetase [CPS], the first enzyme in the urea cycle). 7453791
Schubiger G, Bachmann C, Barben P, Colombo JP, Tönz O, Schüpbach D. N-acetylglutamate synthetase deficiency: diagnosis, management and follow-up of a rare disorder of ammonia detoxication. Eur J Pediatr 1991; 150: 353-6. (Nine year follow up of a patient with NAGS deficiency [Bachman 1981] who was maintained on a protein restricted diet and oral N-carbamylglutamate, but who died during an episode of coma after seizures). 2044610
Colombo JP. N-acetylglutamate synthetase (NAGS) deficiency. Adv Exp Med Biol 1994; 368: 135-43. (Review of the pathogenesis, clinical features and potential therapies of NAGS deficiency which includes use of oral N-carbamylglutamate which is taken up by mitochondria and activates CPS-1 and urea cycle consumption of ammonia). 7741005
Levrat V, Forest I, Fouilhoux A, Acquaviva C, Vianey-Saban C, Guffon N. Carglumic acid: an additional therapy in the treatment of organic acidurias with hyperammonemia? Orphanet J Rare Dis 2008; 3: 2. (Two newborns with severe hyperammonemia were treated successfully with carglumic acid; one with methylmalonic and one propionic aciduria, both associated with decrease in NAGS). 18234091
Thompson CA. Carglumic acid approved to treat genetic hyperammonemia. Am J Health Syst Pharm 2010; 67: 690. (News report announcing approval of carglumic acid by the FDA and explaining its mechanism of action and clinical use). 20410539
Kasapkara CS, Ezgu FS, Okur I, Tumer L, Biberoglu G, Hasanoglu A. N-carbamylglutamate treatment for acute neonatal hyperammonemia in isovaleric acidemia. Eur J Pediatr 2011; 170: 799-801. (A newborn who developed severe hyperammonemia on the 3rd day of life was found to have isovaleric acidemia and was treated with a single dose of carglumic acid [150 mg/kg], with rapid decline in ammonia levels [568 to 72 µg/dL] within 6 hours and the child remained well thereafter on a protein restricted diet). 21207059
Gramage Caro T, Vélez-Díaz-Pallarés M, Serna Pérez J, Bermejo Vicedo T. [Carglumic acid for treatment of valproic acid-induced hyperammonaemia in a paediatric patient]. Farm Hosp 2012; 36: 437-8. Spanish. (A 30 month old boy with refractory epilepsy was treated with valproate for several months and developed hyperammonemia [165.9 µmol/L] with normal routine liver tests, and was treated with carglumic acid while slowly withdrawn from valproate, which was withdrawn with carglumic acid after 58 days with no subsequent increase in ammonia levels). 22858088
Cartagena A, Prasad AN, Rupar CA, Strong M, Tuchman M, Ah Mew N, Prasad C. Recurrent encephalopathy: NAGS (N-acetylglutamate synthase) deficiency in adults. Can J Neurol Sci 2013; 40: 3-9. (Review of the pathogenesis of NAGS and individual case report in a 38 year old man with long history of fluctuating neurologic symptoms who was found to have hyperammonemia [434 µmol/L] and treated successfully with long term carglumic acid). 23250120
Abacan M, Boneh A. Use of carglumic acid in the treatment of hyperammonaemia during metabolic decompensation of patients with propionic acidaemia. Mol Genet Metab 2013; 109: 397-401. (Three children with propionic acidemia with episodic bouts of hyperammonemia were treated with carglumic acid and had improvements in ammonia levels within 24 hours of starting treatment). 23791308
Fernández Colomer B, Rekarte García S, García López JE, Pérez González C, Montes Granda M, Coto Cotallo GD. [Valproate-induced hyperammonemic encephalopathy in a neonate: treatment with carglumic acid]. An Pediatr (Barc) 2014; 81: 251-5. (A 20 day old boy with subdural hematoma and seizures developed hyperammonemia within 2 days of starting valproate [398 µmol/L] and improved rapidly and remained normal after stopping valproate and administration of carnitine, carglumic acid and phenylbutyrate; no mention of adverse events). 24315420
Kasapkara CS, Kanğın M, Taş FF, Topçu Y, Demir R, Ozbek MN. Unusual cause of hyperammonemia in two cases with short-term and long-term valproate therapy successfully treated by single dose carglumic acid. J Pediatr Neurosci 2013; 8: 250-2. (Two boys, ages 1.5 and 15 years, developed hyperammonemia [189 and 283 µg/dL] and confusion while taking valproate for seizures, both responding rapidly without relapse after stopping valproate and administration of a single dose of carglumic acid [100 mg/kg]). 24470826
van Karnebeek CD, Sly WS, Ross CJ, Salvarinova R, Yaplito-Lee J, Santra S, Shyr C, et al. Mitochondrial carbonic anhydrase VA deficiency resulting from CA5A alterations presents with hyperammonemia in early childhood. Am J Hum Genet 2014; 94: 453-61. (Description of 4 children with early onset hyperammonemia who had deficiency of carbonic anhydrase VA, 3 of whom responded to carglumic acid with control of hyperammonemia). 24530203
Lazier J, Lupichuk SM, Sosova I, Khan AA. Hyperammonemic encephalopathy in an adenocarcinoma patient managed with carglumic acid. Curr Oncol 2014; 21: e736-9. (A 24 year old man with metastatic gastric carcinoma developed encephalopathy and hyperammonemia after treatment with cisplatin, epirubicin and capecitabine, and responded to carglumic acid therapy but relapsed on stopping and died in hyperammonemic coma 2 weeks later; genetic testing failed to show a urea cycle disorder or NAGS deficiency). 25302046
Martín-Hernández E, Aldámiz-Echevarría L, Castejón-Ponce E, Pedrón-Giner C, Couce ML, Serrano-Nieto J, Pintos-Morell G, et al. Urea cycle disorders in Spain: an observational, cross-sectional and multicentric study of 104 cases. Orphanet J Rare Dis 2014; 9: 187. (Cross sectional analysis of 104 patients with urea cycle disorders from 98 families and 21 centers in Spain found most common form was ornithine transcarbamylase deficiency [64%], followed by type 1 citrullinemia [21%] and argininosuccinic aciduria [10%], most were treated with essential amino acid replacement, some with sodium benzoate or phenylbutyrate and one with carglumic acid [with NAGS deficiency]). 25433810
Valayannopoulos V, Baruteau J, Delgado MB, Cano A, Couce ML, Del Toro M, Donati MA, et al. Carglumic acid enhances rapid ammonia detoxification in classical organic acidurias with a favourable risk-benefit profile: a retrospective observational study. Orphanet J Rare Dis 2016; 11: 32. (Among 41 patients with organic acidurias who were treated during 48 episodes of hyperammonemia with carglumic acid for 1-15 [mean=5.5] days, all had prompt normalization of ammonia levels [median time to normal 1.5 days] and most adverse events were considered unrelated; no mention of ALT elevations or hepatotoxicity). 27030250
Matoori S, Leroux JC. Recent advances in the treatment of hyperammonemia. Adv Drug Deliv Rev 2015; 90: 55-68. (Review of the causes and treatments of hyperammonemia focusing upon newer agents such as rifaximin, sodium benzoate and phenylbutyrate; carglumic acid is indicated for the rare genetic defect of N-acetylglutamate synthetase deficiency, acting to replace NAG and activate the first enzyme of the urea cycle; no discussion of side effects except for bitter taste). 25895618

## OTHER REFERENCE LINKS

1. Recent References on Carglumic Acid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Carglumic%20Acid)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carglumic%20Acid) Trials on Carglumic Acid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carglumic%20Acid)